# Astragalus

## OVERVIEW

### Introduction

Astragalus is a traditional Chinese herbal medicine used as a general tonic and treatment for many conditions including diarrhea, upper respiratory infections, heart disease, hepatitis and cancer. Astragalus has not been associated with serum enzyme elevations during therapy nor in causing clinically apparent liver injury.

### Background

Astragalus is an ancient traditional Chinese herbal medicine that is derived from roots of various Astragalus species that are native to China, Korea and North America. Called “Huang Qi” in Chinese traditional medcine, it is purported to have immunomodulatory, antioxidant, antiviral and cardiotonic activities and is used to treat stress, fatigue, pain, memory loss, viral infections, hypercholesterolemia, cancer, heart failure, and kidney and liver disease. It is also used as a general tonic to increase energy, reduce fatigue and counteract the effects of aging. Its efficacy in these conditions has not been shown in controlled prospective studies, but it has been used in traditional Chinese medicine for centuries and is currently becoming a popular herbal product in Western countries. Astragalus extracts have multiple chemical constituents and the specific active ingredient responsibility for its activity has not been identified. Constituents include triterpene glycosides, saponins (astragalosides), sterols, fatty acids, isoflavonoids and polysaccharides. Extracts of astragalus are often supplied as tablets or capsules which are taken once to three times daily. Astragalus is also supplied as liquids and teas. Side effects are uncommon and have not been clearly defined. Large doses can cause gastrointestinal upset, diarrhea, nausea and vomiting, probably because of direct irritation to the intestinal mucosa.

### Hepatotoxicity

Astragalus is considered generally safe and without major adverse effects. In the few human studies that have been published there were no reports of serum enzyme elevations occurring during therapy and no mention of serious adverse events or hepatotoxicity. It has been shown to have hepatoprotective activities in animal models and has been used to treat liver diseases, although with uncertain efficacy. There have been no published reports of hepatotoxicity from astragalus, but it is present in many multiingredient products and the purity and potency of commercial preparations are not rigorously regulated. Thus, clinically apparent liver injury attributable to astragalus must be rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which astragalus might cause hepatotoxicity is unclear. The possibility of mislabeling or adulteration with hepatotoxic herbal products is always an issue in commercial multiingredient dietary supplements. In vitro and in vivo studies have reported that astragalus is metabolized by the hepatic microsomal enzyme system and that it has some degree of inhibitory activity against several CYP enzyme isoforms. However, clinically apparent astragalus-drug interactions have not been reported.

### Outcome and Management

Astragalus has not been reported to cause clinically apparent liver injury. Because of its possible effects on CYP activity, its potential for herb-drug interactions should be considered before it is used.

Other Names: Huang Qi, Milk vetch, Radix astragalus

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Astragalus – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/astragalus)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Astragalus | 94166-93-5 | Herbal Extract | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Abbreviations used: HDS, herbal and dietary supplements

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbals are discussed, including comfrey, Jin Bu huan, germander, chaparral leaf, skullcap and valerian, but not astragalus).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbs and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of HDS; astragalus is not discussed).
No authors listed. Astragalus. In, Natural medicines: comprehensive database. http://naturaldatabase.therapeuticresearch.com (Fact sheet on herbal medications and natural products including astragalus).
Astragalus. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 56-61. (Compilation of short monographs on herbal medications and dietary supplements).
Schiano TD. Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis 2003; 7: 453-73. (Comprehensive review of herbal associated hepatotoxicity; astragalus is not listed as causing hepatotoxicity). 12879994
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none were attributed to astragalus). 15390328
McCulloch M, See C, Shu XJ, Broffman M, Kramer A, Fan WY, Gao J, et al. Astragalus-based Chinese herbs and platinum-based chemotherapy for advanced non-small-cell lung cancer: meta-analysis of randomized trials. J Clin Oncol 2006; 24: 419-30. (Systematic review of 34 published controlled trials of astragalus combined with platinum-based chemotherapy for NSCLC found evidence reduced risk of death and improved tumor responses with astragalus, no discussion of adverse events). 16421421
Taixiang W, Munro AJ, Guanjian L. Chinese medical herbs for chemotherapy side effects in colorectal cancer patients. Cochrane Database Syst Rev 2005; (1): CD004540. (Systematic review of published studies on efficacy of Chinese herbal medicines in deceasing side effects of colorectal cancer chemotherapy, identified 4 rather low-quality studies which reported lower rates of nausea and vomiting with Huang Qi; no adverse effects were reported). 15674951
Matkovic Z, Zivkovic V, Korica M, Plavec D, Pecanic S, Tudoric N. Efficacy and safety of Astragalus membranaceus in the treatment of patients with seasonal allergic rhinitis. Phytother Res 2010; 24: 175-81. (Among 48 adults with allergic rhinitis treated with an herbal, vitamin and mineral combination product containing astragalus vs placebo for 6 weeks, allergic symptoms improved more with herbal supplement and “adverse events were not connected with the study drug”). 19504468
Pao LH, Hu OY, Fan HY, Lin CC, Liu LC, Huang PW. Herb-drug interaction of 50 Chinese herbal medicines on CYP3A4 activity in vitro and in vivo. Am J Chin Med 2012; 40: 57-73. (In vitro testing using human microsomes and in vivo testing in rats suggest that Huang Qi was a potent inhibitor of CYP 3A4 activity). 22298448
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and supplements, but astragalus was not present in the list). 22928722
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury does not mention astragalus). 23121117
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to an astragalus-containing product). 25043597
Jiang D, Wang X, Su Q, Jiang S, Yuan F, Zhang C, Gong F, et al. Milkvetch root improves immune function in patients with acute exacerbation of COPD. Biomed Mater Eng 2015; 26 Suppl 1: S2113-21. (Among 82 adults with an acute exacerbation of chronic obstructive lung disease treated with astragalus vs placebo for 2 weeks, improvement in pulmonary function and decrease in inflammatory markers was slightly greater with astragalus treatment and the only adverse reaction recorded was mild diarrhea in 2 subjects). 26405990
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: a tabular listing and clinical characteristics. Int J Mol Sci 2016; 17. pii: E537. (Listing of published cases of liver injury from HDS products does not mention or discuss astragalus). 27070596
Brown AC. Liver toxicity related to herbs and dietary supplements: online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not mention or discuss astragalus). 27402097

## OTHER REFERENCE LINKS

1. Recent References on Astragalus: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Astragalus/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Astragalus: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Astragalus)